# Butorphanol

## OVERVIEW

### Introduction

Butorphanol is a synthetic opioid which is used as a nasal spray for treatment of migraine headaches and parenterally as a narcotic analgesic for moderate-to-severe pain or as an adjunct to general anesthesia. Butorphanol has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Butorphanol (bue tor’ fa nol) is a fully synthetic opioid that has both partial agonist and partial antagonist activity to the µ type opiate receptors, as well as antagonist and partial agonist activity at the ĸ opioid receptor. Engagement of the opiate receptors results in inhibition of intracellular adenylate cyclase, decrease in calcium influx and hyperpolarization of neurons with suppression of action potentials. These actions lead to typical analgesic effects of the opioids. The partial agonist-antagonist activity of butorphanol causes it to antagonize the effects of fully agonist opioids such as morphine and fentanyl, and higher doses of butorphanol do not provide the euphoria typical of full agonists. Butorphanol was first approved for use in the United States in 1978. It remains available as a solution for injection as well as nasal spray (typically for migraine headaches). Indications for the parenteral forms of butorphanol include moderate-to-severe pain that is not responsive to nonnarcotic analgesia. Butorphanol is available generically and previously under the brand names Stadol as a solution for injection and nasal spray in concentrations of 10 mg/mL. Typical doses vary by indication and clinical response. Side effects include sedation, respiratory depression, confusion, euphoria, agitation, itching, sweating, abdominal bloating, nausea, vomiting and constipation, adverse effects which are typical of the opioids, although gastrointestinal side effects may be less. Butorphanol has a lower potential for physical and psychological dependency than morphine, fentanyl and oxycodone and is classified as a Schedule IV drug, indicating that it has medical usefulness, and only a low potential for physical and psychological dependency and abuse.

### Hepatotoxicity

Therapy with butorphanol has not been linked to serum enzyme elevations during therapy or to instances of idiosyncratic, clinically apparent liver injury. It is generally given for short periods of time for acute pain only and experience with prolonged use is limited.

References on the safety and potential hepatotoxicity of butorphanol are given in the Overview section of the Opioids.

Drug Class: Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Butorphanol – Generic, Dolorex® (previously Stadol®)

DRUG CLASS

Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Butorphanol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Butorphanol | 58786-99-5 | C21-H29-N-O2.C4-H6-O6 | Butorphanol Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Butorphanol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Butorphanol+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Butorphanol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Butorphanol)